# Capmatinib

## OVERVIEW

### Introduction

Capmatinib is an orally available, small molecule inhibitor of the mesenchymal-epithelial transition (MET) factor tyrosine kinase receptor that is used in selected patients with non-small cell lung cancer (NSCLC). Serum aminotransferase elevations are common during therapy with capmatinib, which rarely can lead to clinically apparent liver injury that can be severe and even fatal.

### Background

Capmatinib (kap ma’ ti nib) is an orally available, small molecule inhibitor of the mesenchymal-epithelial transition (MET) factor tyrosine kinase receptor that blocks the binding of its ligand, hepatocyte growth factor (HGF), which normally activates signaling pathways involved in cell proliferation, motility, and invasion. The MET gene is mutated or overexpressed in several human cancers, including lung, liver, breast, and ovarian leading to uncontrolled cell growth and proliferation. Capmatinib has potent activity against selected mutated forms of the MET receptor, including the variant produced by exon 14 skipping, and was found to inhibit cancer cell growth in several tissue culture and animal models of MET dysregulated cancers. In moderately sized, open label trials, capmatinib was found to induce objective responses in 41% of patients with refractory, metastatic non-small cell lung cancer harboring MET mutations and a higher proportion of treatment-naïve subjects. Capmatinib was approved in the United States in 2020 for adults with NSCLC with documented mutations that cause MET exon 14 skipping, the first neoplastic agent approved for this indication. It remains under evaluation for other forms of cancer harboring MET mutations. Capmatinib is available in tablets of 150 and 200 mg under the brand name Tabrecta. The recommended dose is 400 mg orally twice daily until disease progression or unacceptable toxicity. Side effects are common and arise in almost all patients treated with capmatinib and lead to dose modification or discontinuation in approximately one quarter of treated patients. Common side effects include edema, nausea and vomiting, anorexia, diarrhea or constipation, musculoskeletal pain, fatigue, fever, cough, dyspnea, and rash. Uncommon but potentially severe adverse events include pneumonitis, interstitial lung disease, hepatotoxicity, photosensitivity, hypersensitivity reactions, and embryo-fetal toxicity.

### Hepatotoxicity

In the prelicensure clinical trials of capmatinib in patients with solid tumors harboring MET mutations, liver test abnormalities were frequent although usually self-limited and mild. Some degree of ALT elevations arose in 39% of capmatinib treated patients and were above 5 times the upper limit of normal (ULN) in 7%. In these trials that enrolled 373 patients, capmatinib was discontinued early due to increased AST or ALT in only 1% of patients. The liver test abnormalities had a median onset of 2 months after initiation of therapy. While serum aminotransferase elevations were occasionally quite high (5 to 20 times upper limit of normal), there were no accompanying elevations in serum bilirubin and no patient developed clinically apparent liver injury with jaundice. The product label for capmatinib recommends monitoring for routine liver tests before, at 2-week intervals during the first 3 months of therapy, and monthly thereafter as clinically indicated. However, since its approval and more wide-spread clinical use, there have been several reports of acute liver injury with jaundice in patients receiving capmatinib. The onset is after 6 to 8 weeks, and the clinical pattern is hepatocellular with features resembling severe acute viral hepatitis. Immune allergic and autoimmune features are not common, and recovery occurs typically within 2 to 3 months, but at least one fatal incident has been reported. Strikingly, most cases have occurred shortly after previous chemotherapy with a checkpoint inhibitor (within 2 to 4 months of the last dose). A similar frequent occurrence of liver injury following recent use of checkpoint inhibitors has been reported with other kinase inhibitors (sotorasib, crizotinib, osimertinib). These findings suggest that capmatinib not be started within 4 months of the last dose of a checkpoint inhibitor.

Likelihood score: C (probable uncommon cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of serum aminotransferase elevations from capmatinib is unknown, but the pattern of abnormalities suggests idiosyncratic and perhaps an immune-mediated liver injury, the risk of which is increased if the kinase inhibitor is started within 3 to 4 months of a dose of an immune checkpoint inhibitor. Capmatinib is metabolized in the liver via the cytochrome P450 system, largely CYP 3A4 and 1A2, and is susceptible to drug-drug interactions with agents that inhibit or induce these CYPs. Therefore, drugs that inhibit CYP 3A4 or 1A2 activity should be avoided or the dose of capmatinib adjusted accordingly.

### Outcome and Management

The product label for capmatinib recommends monitoring for routine liver tests before starting treatment, at 2 week intervals during the first 3 months of treatment and monthly thereafter as clinically indicated. Serum aminotransferase elevations above 5 times the upper limit of normal (if confirmed) should lead to dose reduction or temporary cessation of capmatinib therapy and careful monitoring. Restarting therapy at a reduced dose can be done with caution and continued monitoring. In patients with jaundice or symptoms of liver injury accompanying the serum aminotransferase elevations, capmatinib should be promptly discontinued and not restarted. Several reports have suggested a benefit from use of ursodiol and N-acetyl cysteine. These agents have not been proven to be beneficial in this situation, but they are generally safe. Cross sensitivity to liver injury is uncommon among the antineoplastic, small molecule enzyme and tyrosine receptor inhibitors, but currently there is no information on shared adverse event sensitivity of capmatinib with other antineoplastic kinase inhibitors.

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

Other Related Drugs: Tepotinib

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Capmatinib – Tabrecta®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Capmatinib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Capmatinib | 1029712-80-8 | C23-H17-F-N6-O

## ANNOTATED BIBLIOGRAPHY

References updated: 25 April 2025

Abbreviations: MET, mesenchymal epithelial transition receptor kinase gene; NSCLC, non-small cell lung cancer.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of tyrosine kinase receptor inhibitors).
DeLeve LD. Kinase inhibitors. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents, does not discuss capmatinib).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
FDA. 2020. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2020/213591Orig1s000MultidisciplineR.pdf (FDA website with initial multidiscipline clinical review of the safety and efficacy of capmatinib; states that the overall objective response rate was 68% in treatment naïve and 41% in treatment refractory patients, and that adverse events arose in up to 50% of patients which were considered serious adverse events in 13%; ALT elevations occurred in 38% of patients and were above 5 times ULN in 8%, leading to dose interruption or adjustment in 5% and early discontinuation in 1%, but there were cases of acute liver injury with jaundice or hepatic failure and no fatalities due to liver injury attributed to capmatinib therapy).
Awad MM, Oxnard GR, Jackman DM, Savukoski DO, Hall D, Shivdasani P, Heng JC, et al. MET exon 14 mutations in non-small-cell lung cancer are associated with advanced age and stage-dependent MET genomic amplification and c-Met overexpression. J Clin Oncol. 2016;34:721-30. (Among 6376 cancers undergoing genome sequencing, MET exon 14 mutations were found in 28 of 933 [3%] NSCLC, KRAS mutations in 34%, EGFR in 19%, ALK 4% and BRAF in 4%; those with the MET exon 14 skipping mutations tended to be older than those with KRAS or EGFR mutations). 26729443
Wolf J, Seto T, Han JY, Reguart N, Garon EB, Groen HJM, Tan DSW, et al.; GEOMETRY mono-1 Investigators. Capmatinib in MET exon 14-mutated or MET-Amplified non-small-cell lung cancer. N Engl J Med. 2020;383:944-957. (Among 364 patients with MET-dysregulated advanced NSCLC treated with capmatinib [400 mg twice daily], overall response rates were 68% for treatment naïve and 41% in previously treated refractory subjects, while adverse events arose in most patients [98%] and included peripheral edema [51%], nausea [45%], dyspnea [23%], fatigue [22%], anorexia [21%], and ALT elevations [13%] which were above 5 times ULN in 6%, and while one death was attributed to hepatitis, it was judged to be unrelated to treatment). 32877583
Dhillon S. Capmatinib: first approval. Drugs. 2020;80:1125-1131. (Review of the mechanism of action, history of development, pharmacology, clinical efficacy and safety of capmatinib shortly after its accelerated approval as therapy of MET dysregulated NSCLC in the US, mentions that ALT elevations were a prominent reason for dose reductions during therapy). 32557339
Mathieu LN, Larkins E, Akinboro O, Roy P, Amatya AK, Fiero MH, Mishra-Kalyani PS, et al. FDA approval summary: capmatinib and tepotinib for the treatment of metastatic NSCLC harboring MET Exon 14 skipping mutations or alterations. Clin Cancer Res. 2022;28:249-254. (Summary of the data supporting the FDA accelerated approvals of capmatinib and tepotinib for metastatic NSCLC with MET exon 14 skipping mutations or alterations, mentions that the safety profiles were similar for the two agents, both of which had evidence of hepatotoxicity considered serious enough to include in the “Warnings and Precautions” sections of the product labels). 34344795
Illini O, Fabikan H, Swalduz A, Vikström A, Krenbek D, Schumacher M, Dudnik E, et al. Real-world experience with capmatinib in MET exon 14-mutated non-small cell lung cancer (RECAP): a retrospective analysis from an early access program. Ther Adv Med Oncol. 2022;14: 17588359221103206.35720834
(Among 81 adults with NSCLC and MET exon 14 skipping mutation treated with capmatinib over a 2.5- year period in an open-label early access program, the overall response rate was 58% and safety was considered “manageable”, with “liver enzyme” elevations in 7%, which were above 5 times ULN in 3% and leading to discontinuation in 2%; no mention of clinically apparent liver injury) .
Capmatinib (Tabrecta) for NSCLC. Med Lett Drugs Ther. 2023;65:e65-e66. (Concise summary of the mechanism of action, clinical efficacy, adverse effects, and costs of capmatinib shortly after it was granted regular approval for use in NSCLC with MET exon 14 skipping mutations, which occur in 3-4% of NSCLC cases, mentions that hepatotoxicity “can occur”). 37039616
Valencia Soto CM, Martínez Callejo V, García-Avello Fernández-Cueto A, Villacañas Palomares MV, Barbadillo Villanueva S, Ochagavía Sufrategui M, López-Brea Piqueras MF, et al. Severe hepatotoxicity during treatment with capmatinib. J Oncol Pharm Pract. 2023;29:1484-1488.37157816
(Elderly woman with lung adenocarcinoma and MET exon 14 skipping mutation developed acute liver injury 7 weeks after starting capmatinib [initiated shortly after stopping pembrolizumab] with rapidly progressive hepatic failure and death [peak bilirubin ~10 mg/dL, ALT ~3600 U/L, Alk P not given, INR “out of range ”).
Sisi M, Vitale G, Fusaroli M, Riefolo M, Giunchi V, D'Errico A, Ardizzoni A, et al. Capmatinib-induced liver injury as emerging toxicity of MET inhibitors in patients with NSCLC pretreated with immune checkpoint inhibitors. JTO Clin Res Rep. 2023;4:100563.37745898
(64 year old man and 82 year old woman with NSCLC developed liver injury after 9 and 6 weeks of capmatinib therapy [peak bilirubin 8.9 and 4.6 mg/dL, ALT 1689 and 955 U/L, Alk P 255 and 229 U/L], both having stopped chemotherapy with pembrolizumab 8 and 14 weeks previously, and both resolving the injury 3 and 2 months after stopping capmatinib on treatment with ursodiol and N-acetyl cysteine) .
Aiad M, Bhalala HJ, Bagshaw H, Starner S, Saha D. Severe hepatotoxicity from capmatinib: a case report and therapeutic approach. Cureus. 2025;17:e77652.39968425
(50 year old man with NSCLC and MET exon 14 skipping mutation treated with chemotherapy including atezolizumab, developed acute liver injury starting 4 weeks after switching to capmatinib [peak bilirubin 19.1 mg/dL, ALT 1773 U/L, Alk P 440 U/L] resolving within 8 weeks of stopping and treatment with ursodiol and N-acetyl cysteine) .

## OTHER REFERENCE LINKS

Recent References on Capmatinib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Capmatinib/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

Trials on Capmatinib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Capmatinib)